# Causality

Drug induced liver injury is a diagnosis of exclusion that rests upon ruling out other common causes of liver disease, and knowledge of the pattern of injury associated with the specific drug. Unlike in hepatitis A or B, for instance, there are no specific diagnostic tests that establish causality for drug induced liver injury. The diagnosis can be very challenging, and even experts can disagree on the likelihood of the causality. For these reasons, attempts have been made to standardize causality assessment in drug induced adverse events. These methods generally rely upon careful delineation of the timing of onset of the adverse event in relation to starting the medication (challenge), and the timing of resolution in relation to stopping the medication (dechallenge). The causality is greatly strengthened if there is a recurrence on reexposure (rechallenge). Other helpful features are signs and symptoms of hypersensitivity, known drug allergies, the absence of competing diagnoses, and previous information on the occurrence of a similar adverse event with the medication. These factors are variously captured in the causality instruments and given various weights to achieve a rating score for the likelihood of the medication causing the injury. Commonly used instruments include the Naranjo Probability Scale, which is not specific to liver injury and can be used for any type of adverse drug reaction. In contrast, the Roussel Uclaf Causality Assessment Method (RUCAM) and its modification known as the Maria and Victorino (M & V) System, were developed specifically for drug induced liver injury. All three causality instruments have been used widely and perform reasonably well in comparison to the "gold standard" of expert opinion.

## RUCAM Scale

The RUCAM scale was developed after an international meeting in Paris in 1989, under the auspices of the Council for International Organizations of Medical Scientists (CIOMS), directed at developing uniform diagnostic criteria for drug induced liver injury. The eight international experts invited to the meeting created a diagnostic instrument that came to be referred to as RUCAM (Roussel Uclaf Causality Assessment Method). Points are awarded for seven components:

- Time to onset of the injury following start of the drug
- Subsequent course of the injury after stopping the drug
- Specific risk factors (age, alcohol use, pregnancy)
- Use of other medications with a potential for liver injury
- Exclusion of other causes of liver disease
- Known potential for hepatotoxicity of the implicated drug
- Response to rechallenge

Total scores range from less than 0 to 14 with scores of 3 or below indicating unlikely, 4-5 possible, 6-8 probable, and >8 highly probable hepatotoxicity. Although available for almost three decades, RUCAM is not commonly used in clinical practice and does not have full endorsement even by specialists in hepatotoxicity. One reason is that many of the factors included in the RUCAM score are not well described and open to variable interpretation. Another reason is that it is difficult to develop a single instrument that is accurate for all forms of drug induced liver injury. A more thorough discussion of the RUCAM including a printable copy of the RUCAM form and a manual of operation for its completion is given below.

- Roussel Uclaf Causality Assessment Method (RUCAM)

## Maria & Victorino (M & V) Scale

A second scale was developed by investigators from Portugal and referred to as the M & V Clinical scale. In this instrument, points are awarded for five components:

- Time to onset of the injury following start of the drug
- Exclusion of other causes of liver disease
- Extrahepatic manifestations (rash, fever, eosinophilia, cytopenia)
- Known potential for hepatotoxicity of the implicated drug
- Response to rechallenge

The value of this scale was later examined by investigators in the United Kingdom who concluded that it compared favorably to developed international consensus criteria for adverse drug reactions. A larger study from Spain, in contrast, directly compared the RUCAM and the M & V scale on a large number of cases and concluded that RUCAM was the preferable instrument. A more complete discussion of the M & V scale as well as a printable copy of the scale and a manual of operations is given below.

- Maria & Victorino (M & V) System of Causality Assessment

## Naranjo Scale

The Naranjo scale was developed as a means of assessment of causality of any form of adverse drug reaction. Thus, the Naranjo scale is not specific for liver injury. Points are given for ten elements including time to onset, recovery, previous reports of similar injury, response to rechallenge and possibility of alternative causes. The Naranjo scale is easy to apply and is widely used in assessing adverse drug reactions, particularly in clinical trials. A more complete description of the Naranjo scale as well as a printable copy of the form and a manual of operations for its calculation is given below.

- Adverse Drug Reaction Probability Scale (Naranjo)

## Bayesian Assessment

Another approach yet to be fully developed is Bayesian assessment for determining adverse drug reactions. This assessment, together with a scale developed by Naranjo, addresses the issue of adverse drug reactions of all types, not specifically that of drug induced liver injury. Bayesian assessment requires specific information on the frequency of the injury in exposed and unexposed persons and is a highly statistically based method not appropriate for use in clinical practice. More work is needed on these rather complicated approaches.

## Causality Assessment by Expert Opinion

The most commonly used method to adjudicate causality, however, is “expert opinion.” In instances of official appraisal of a drug for potential hepatotoxicity, one or more experts with experience in evaluating drug induced liver injury render a personal opinion on the validity of the association after reviewing all existing data. This method is obviously restricted in applicability and dependent upon somewhat subjective judgment. While commonly used, it is unclear whether expert opinion is more accurate than the published scoring systems such as the RUCAM and M & V scales.

## Causality Assessment in the Drug-Induced Liver Injury Network

To help with consistency and uniformity in the process of expert opinion, the group of investigators participating in the Drug-Induced Liver Injury Network (DILIN) study worked to develop a standardized method of performing assessment of the likelihood that a medication is the cause of liver injury in individual cases of potential hepatotoxicity. For purposes of causality assessment, a narrative summary, summary of clinical findings, and sequential biochemical abnormalities are provided to three experts in hepatotoxicity. Causality assessment is made independently by the experts who grade the likelihood of a causal relationship between the drug and liver injury in one of five scores:

Definite | ………………… | Greater than 95%
Very likely | ………………… | 75-95%
Probable | ………………… | 50-75%
Possible | ………………… | 25-50%
Unlikely | ………………… | Less than 25%

The five levels of causality are also defined in textual and legal terms.

Definite (>95% assurance) implies that the association is “beyond a reasonable doubt”; that the agent is known to cause liver injury; the drug causes a specific clinical pattern of liver injury; and, that other possible competing diagnoses have been adequately and convincingly ruled out.

Very likely (75% to 95% assurance) suggests that the association is “clear and convincing”; that the agent is known to cause liver injury; and, that most, but perhaps not all, competing diagnoses have been excluded or the pattern of injury is not completely typical.

Probable (50% to 75% assurance) suggests that “the predominance of the evidence” supports the association. The agent may not have been previously linked to liver disease; and/or the pattern of injury may be atypical; and/or not all competing diagnoses have been completely excluded. Nevertheless, the reviewer believes that the weight of the evidence is in favor of the drug having caused the liver injury.

Possible (25% to 50% assurance) suggests that the association is weak but cannot be ruled out completely. Perhaps the agent has not been clearly linked to liver injury; or, the pattern of injury is unusual for the medication; or, another cause of liver injury is present.

Unlikely (<25% assurance) suggests that the liver injury is clearly due to another condition or its association with the medication is not at all convincing.

While the five terms to grade causality are vague, attempts are made to provide an objective and critical evaluation of the likelihood that the liver injury is due to the suspected agent. Cases are not considered “probable” merely because there is no other explanation for the liver injury. Similarly, cases are not considered “definite” if another diagnosis is possible. If two or three drugs are implicated, only one can be considered probable, highly likely or definite and the others are assigned possible or unlikely scores so that the total percent assurance is not more than 100%.

The causality assessment is accepted as initially scored if there is complete agreement among the three expert reviewers. If there is disagreement, the reviewers meet to reconcile the differences and reach a final single score.

## Comparison of Probability Scales

Scales for assessing causality in drug induced liver injury use four or five levels of likelihood and somewhat different terms, making direct comparisons of different scales difficult, as shown in the Table below. The World Health Organization has suggested that there be four levels of likelihood applied to adverse reaction causality assessment: certain, probable, possible, and unlikely. A comparison of the different scales in given in the Table. The differences in the scales are either at the top (mostly likely: separating “definite” from “highly likely” in the DILIN scale) or at the bottom (least likely: separating “not likely” from “excluded” in the RUCAM and M & V scales).

WHO 4 Levels | Naranjo 4 Levels | RUCAM 5 Levels | M & V 5 Levels | DILIN 5 Levels
Level 1 [Certain] | Definite | Highly Probable | Definite | Definite and Highly Likely
Level 2 [Probable] | Probable | Probable | Probable | Probable
Level 3 [Possible] | Possible | Possible | Possible | Possible
Level 4 [Unlikely] | Doubtful | Not Likely and Excluded | Not Likely and Excluded | Unlikely

Causality Assessment Tools